# Lanreotide

## OVERVIEW

### Introduction

Lanreotide is a synthetic polypeptide analogue of somatostatin that resembles the native hormone in its ability to suppress levels and activity of growth hormone, insulin, glucagon and many other gastrointestinal peptides. Because its half-life is longer than somatostatin, lanreotide can be used clinically to treat neuroendocrine tumors that secrete excessive amounts of growth hormone (acromegaly) or other active hormones or neuropeptides. Lanreotide has many side effects including suppression of gall bladder contractility and bile production, and maintenance therapy may cause cholelithiasis and pancreatitis as well accompanying liver injury.

### Background

Lanreotide (lan ree' oh tide) is a synthetic octapeptide and analogue of somatostatin that is used for its ability to suppress levels and activities of hormones (growth hormone, insulin, gastrin, secretin, glucagon) or active neuropeptides (serotonin, vasoactive intestinal polypeptide [VIP]). Natural somatostatin is produced in the hypothalamus and acts to suppress growth hormone release from the pituitary. Somatostatin is also found in other neurons throughout the body and particularly in intestinal and pancreatic neurons, where it is active in suppressing release of hormones and neuropeptides such as insulin, glucagon, gastrin, secretin, motilin, VIP, serotonin and cholecystokinin. Because of its short half-life (~3 minutes), somatostatin is impractical as a therapeutic agent, and analogues have been developed that have a more favorable pharmacological profile such as octreotide, pasireotide and lanreotide, all three of which have been marketed in long acting release (LRA) forms to allow once weekly or monthly administration. Lanreotide appears to interact largely with the somatostatin subtype 2 and possibly subtype 5 receptors, with little effect on subtypes 1, 3 and 4, but otherwise acts in a similar manner to somatostatin. Lanreotide therapy has been shown to improve symptoms and complications of several neuroendocrine tumors including abnormal growth in acromegaly due to growth hormone-secreting pituitary tumors, diarrhea due to VIP-secreting intestinal tumors, and flushing due to serotonin-producing carcinoid tumors. Lanreotide was approved for use in the United States in 2007 and current listed indications include acromegaly and unresectable, locally advanced or metastatic gastroenteropancreatic neuroendocrine tumors. Lanreotide has been used off label for polycystic liver and kidney disease. A long acting form of lanreotide is available under the brand name Somatuline Depot in prefilled syringes of 60 mg in 0.2 mL, 90 mg in 0.3 mL or 120 mcg in 0.5 mL (240 mg/mL). Lanreotide depot is administered as a deep subcutaneous injection every 4 weeks in doses of 60 to 120 mg each. Side effects are common. Adverse events from single injections include influenza-like symptoms of fatigue, headache, nausea and vomiting and local injection reactions. With continued therapy, common adverse events include diarrhea, abdominal pain, back pain, headache, dizziness, hypothyroidism, hypo- and hyperglycemia, arrhythmias and gallbladder disease.

### Hepatotoxicity

In preregistration studies of lanreotide, serum enzyme levels did not change appreciably and there were no reports of clinically apparent acute liver injury. Pooled analyses reported that there were no overall changes in serum ALT, AST or alkaline phosphatase levels during therapy or instances of clinically meaningful elevations with treatment. Prolonged therapy with lanreotide, as with other somatostatin analogues, was associated with a high rate of biliary sludge and cholelithiasis, probably due to inhibition of gall bladder contractility and decrease in bile secretion. In long term studies, cholelithiasis developed in 20% to 33% of lanreotide treated patients. In some instances, symptomatic cholecystitis occurred which can be accompanied by mild-to-moderate elevations in serum enzymes and bilirubin. However, most lanreotide associated gallstones were asymptomatic. Unlike octreotide, lanreotide and other long acting somatostatin analogues have not been liked to cases of clinically apparent liver injury, independent of cholelithiasis or biliary sludge, although they have had more limited use and have not been used in many of the clinical situations that were treated with octreotide (portal hypertension, variceal hemorrhage and infants with congenital hyperinsulinemia).

Likelihood score: E* (unproven but suspected rare cause of clinically apparent hepatobiliary injury).

### Mechanism of Injury

Lanreotide, like somatostatin, decreases cholecystokinin secretion, gall bladder contractility and bile secretion, perhaps accounting for the high rate of gall bladder sludge and stone formation with long term use. How lanreotide might cause acute liver injury independent of its effect on bile flow and gall bladder function is uncertain. Lanreotide is a polypeptide and, as such, should not have direct or even indirect hepatic toxicity. On the other hand, lanreotide has multiple effects on the gastrointestinal tract, including effects on gastrointestinal hormone levels, motility, transit time, bacterial flora, and bile acid concentrations, all of which may have indirect effects on the liver.

### Outcome and Management

The liver injury due to the lanreotide is generally due to its effects on the gallbladder and bile flow. Patients with hepatobiliary complications of lanreotide therapy are likely to have recurrence with restarting and have similar response to other somatostatin analogues such as octreotide and pasireotide.

Drug Class: Hormonal Agents; Antineoplastic Agents; Gastrointestinal Agents

Other Drugs in the Subclass, Hormonal Agents, Somatostatin Analogues: Octreotide, Pasireotide

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lanreotide – Somatuline Depot®

DRUG CLASS

Hormonal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lanreotide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lanreotide | 108736-35-2 | C54-H69-N11-O10-S2
Octreotide | 83150-76-9 | C49-H66-N10-O10-S2 | Octreotide structure
Pasireotide | 396091-73-9 | C58-H66-N10-O9
Somatostatin | 51110-01-1 | Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 11 April 2017

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 589-637. (Expert review of hepatotoxicity published in 1999 and before the availability of lanreotide).
Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. 3rd edition. Amsterdam: Elsevier, 2013. (Multiauthored text book on drug induced liver injury; does not discuss lanreotide).
Sharkey KA, MacNaughton WK. Gastrointestinal motility and water flux, emesis and biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 921-44. (Textbook of pharmacology and therapeutics).
Caron P, Morange-Ramos I, Cogne M, Jaquet P. Three-year follow-up of acromegalic patients treated with intramuscular slow-release lanreotide. J Clin Endocrinol Metab 1997; 82: 18-22. (Among 22 acromegalic patients treated with lanreotide every 10-14 days for at least 3 years, 13 had minor digestive symptoms during the 48 hours after each injection and 4 developed gallstones). 8989225
van Keimpema L, Nevens F, Vanslembrouck R, van Oijen MG, Hoffmann AL, Dekker HM, de Man RA, Drenth JP. Lanreotide reduces the volume of polycystic liver: a randomized, double-blind, placebo-controlled trial. Gastroenterology 2009; 137: 1661-8. (Among 54 patients with polycystic liver disease treated with lanreotide or placebo every 4 weeks for 24 weeks, the average liver size decreased by 2.9% with lanreotide and increased with placebo, while side effects were limited to 1-4 days of loose stools after each injection and there were no changes in routine liver test results). 19646443
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to a somatostatin analogue). 20949552
Chrispijn M, Nevens F, Gevers TJ, Vanslembrouck R, van Oijen MG, Coudyzer W, Hoffmann AL, et al. The long-term outcome of patients with polycystic liver disease treated with lanreotide. Aliment Pharmacol Ther 2012; 35: 266-74. (Among 41 patients who completed a placebo controlled study of 6 months of lanreotide for polycystic liver disease [van Keimpema 2009] and who were continued on drug [120 mg per month] for another 12 months, liver size did not decrease further while “liver enzyme values remained constant”). 22111942
Temmerman F, Gevers T, Ho TA, Vanslembrouck R, Coudyzer W, van Pelt J, Bammens B, et al. Safety and efficacy of different lanreotide doses in the treatment of polycystic liver disease: pooled analysis of individual patient data. Aliment Pharmacol Ther 2013; 38: 397-406. (In a pooled analysis of studies of lanreotide therapy of polycystic liver disease, higher doses [120 vs 90 mg] were associated with greater reduction in liver size, but adverse event rates were similar; no mention of ALT elevations or cholelithiasis). 23799922
Caplin ME, Pavel M, Ćwikła JB, Phan AT, Raderer M, Sedláčková E, Cadiot G, et al.; CLARINET Investigators. Lanreotide in metastatic enteropancreatic neuroendocrine tumors. N Engl J Med 2014; 371: 224-33. (Among 204 patients with metastatic neuroendocrine tumors treated with lanreotide or placebo every 4 weeks for 96 weeks, progression free survival was prolonged by lanreotide, but the overall rates of adverse events were similar; those more frequent with lanreotide were diarrhea, abdominal pain, cholelithiasis(10%], flatulence, nausea, headache and lethargy; one patient developed “liver decompensation” the day after the first injection, but ultimately recovered). 25014687
Gevers TJ, Hol JC, Monshouwer R, Dekker HM, Wetzels JF, Drenth JP. Effect of lanreotide on polycystic liver and kidneys in autosomal dominant polycystic kidney disease: an observational trial. Liver Int 2015; 35: 1607-14. (Among 43 patients with autosomal dominant polycystic kidney disease treated with lanreotide for at least 6 months, mean liver volume decreased by an average of 3.1% and there were no “clinically relevant or statistically significant changes” in laboratory results and no patient developed symptomatic cholecystitis). 25369108
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to octreotide, but none to lanreotide). 25754159
Sagvand BT, Khairi S, Haghshenas A, Swearingen B, Tritos NA, Miller KK, Klibanski A, et al. Monotherapy with lanreotide depot for acromegaly: long-term clinical experience in a pituitary center. Pituitary 2016; 19: 437-47. (Compared to 39 surgically cured patients with acromegaly, 24 who were treated with lanreotide depot for at least 24 months were more likely to have gastrointestinal symptoms such as diarrhea, abdominal pain, and nausea and 9% [vs 0%] developed gallstones, but there were no significant changes in ALT, AST or alkaline phosphatase levels and no episodes of clinically apparent liver injury). 27155600
Öberg K, Lamberts SW. Somatostatin analogues in acromegaly and gastroenteropancreatic neuroendocrine tumours: past, present and future. Endocr Relat Cancer 2016; 23: R551-R566. (Review of the use of somatostatin analogues such as oct-, pasi- and lan-reotide for acromegaly and neuroendocrine tumors; mentions that one-third to one-half of patients on somatostatin analogues can develop gallstones or biliary sludge). 27697899

## OTHER REFERENCE LINKS

1. Recent References on Lanreotide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lanreotide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lanreotide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lanreotide)